# Omacetaxine

## OVERVIEW

### Introduction

Omacetaxine is a semisynthetic cephataxine that acts as a protein translation inhibitor and is used to treated chronic myeloid leukemia that is resistant to tyrosine kinase receptor antagonists. Omacetaxine is associated with a low rate of serum enzyme elevation during therapy, but has not been linked to cases of clinically apparent liver injury with jaundice.

### Background

Omacetaxine (oh" ma se tax' een) mepesuccinate is a semisynthetic molecule previously known as homoharringtonine which is derived from the leaves and bark of Cephalotaxus harringionia (plum yew). Omacetaxine is an inhibitor of protein translation which binds to ribosomes and blocks the initial elongation step in the synthesis of proteins from mRNA. Therapy with omacetaxine was found to have activity against chronic myeloid leukemia (CML) and was considered a first line agent before the introduction of the tyrosine kinase inhibitor imatinib. More recently, omacetaxine has found to improve survival in patients with refractory CML and resistance to multiple tyrosine kinase inhibitors and was approved for this use in the United States in 2012. Omacetaxine is administered parenterally and is available in single use vials of 3.5 mg of lyophilized powder for reconstitution. The recommended dose is 1.25 mg/m^2^ injected subcutaneously twice daily on days 1 to 14 of 28-day cycles, with subsequent modification once remission is achieved to twice daily on days 1 to 7 of 28-day cycles. Common side effects include myelosuppression which can be severe, injection site reactions, diarrhea, fatigue, weakness, nausea, headache, pyrexia and infections. Uncommon, but potentially severe adverse events include neutropenic fever and sepsis, cerebral hemorrhage and hyperglycemia.

### Hepatotoxicity

In controlled trials, serum aminotransferase elevations occurred in 2% to 6% patients treated with omacetaxine, but most elevations were mild and transient with only rare patients requiring dose modification or discontinuation for liver test abnormalities. Clinically apparent liver injury with jaundice was not reported in the preregistration trials of omacetaxine and is not mentioned in the product label. Since the approval and more wide scale use of omacetaxine, there have been no publications or descriptions of the hepatotoxicity with jaundice associated with its use. Thus, clinically apparent liver injury due to omacetaxine must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the liver enzyme elevations that occur during therapy with omacetaxine is unknown, but may be unrelated to the medication. Omacetaxine is metabolized mostly by circulating plasma esterases and has little hepatic metabolism. Omacetaxine exhibits no known drug-drug interactions.

### Outcome and Management

The liver injury linked to omacetaxine therapy has been generally mild, consisting of transient and asymptomatic elevations in serum aminotransferase levels. Omacetaxine has not been linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no reason to suggest that there is cross sensitivity to hepatic injury between omacetaxine and therapies of CML.

Drug Class: Antineoplastic Agents, Chronic Myeloid Leukemia Agents

Other Drugs in the Subclass, Chronic Myeloid Leukemia Agents: Bosutinib, Dasatinib, Imatinib, Nilotinib, Ponatinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Omacetaxine – Synribo®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Omacetaxine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Omacetaxine | 26833-87-4 | C29-H39-N-O9 | Omacetaxine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 06 January 2017

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999 before the availability of omacetaxine).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam, Elsevier, 2013, p. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; omacetaxine is not discussed).
Moy B, Lee RJ, Smith M. Hormone therapy in prostate cancer. Natural products in cancer chemotherapy: hormones and related agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1763-9. (Textbook of pharmacology and therapeutics).
Cortes J, Lipton JH, Rea D, Digumarti R, Chuah C, Nanda N, Benichou AC, et al.; Omacetaxine 202 Study Group. Phase 2 study of subcutaneous omacetaxine mepesuccinate after TKI failure in patients with chronic-phase CML with T315I mutation. Blood 2012; 120: 2573-80. (Among 62 patients in the chronic phase of CML with a T351I mutation in the BCR-ABL gene and failure of imatinib therapy treated with omacetaxine [1-41 cycles], the hematologic response rate was 77% and side effects were largely due to myelosuppression; ALT elevations above 5 times ULN occurred in 2 patients [3%], but there were no liver related serious adverse events or discontinuations). 22896000
Cortes J, Digumarti R, Parikh PM, Wetzler M, Lipton JH, Hochhaus A, Craig AR, et al.; Omacetaxine 203 Study Group. Phase 2 study of subcutaneous omacetaxine mepesuccinate for chronic-phase chronic myeloid leukemia patients resistant to or intolerant of tyrosine kinase inhibitors. Am J Hematol 2013; 88: 350-4. (Among 46 patients with CML in the chronic phase refractory to at least 2 tyrosine kinase inhibitors treated with omacetaxine [1 to 39 cycles], hematologic responses occurred in 67% and overall survival averaged 30 months, while side effects included thrombocytopenia [67%], anemia [54%], neutropenia [50%], infection [57%], diarrhea [44%], nausea [30%], fatigue [24%], and headache [20%]; there were no liver related serious adverse events, drug discontinuations or delays). 23468307
Daver N, Vega-Ruiz A, Kantarjian HM, Estrov Z, Ferrajoli A, Kornblau S, Verstovsek S, et al. A phase II open-label study of the intravenous administration of homoharringtonine in the treatment of myelodysplastic syndrome. Eur J Cancer Care (Engl) 2013; 22: 605-11. (Among 9 patients with myelodysplasic syndromes treated with intravenous homoharringtonine [1-3 cycles], one had a complete response and 8 no response while side effects included serious cardiac and renal toxicities). 23701251
Cortes JE, Nicolini FE, Wetzler M, Lipton JH, Akard L, Craig A, Nanda N, et al. Subcutaneous omacetaxine mepesuccinate in patients with chronic-phase chronic myeloid leukemia previously treated with 2 or more tyrosine kinase inhibitors including imatinib. Clin Lymphoma Myeloma Leuk 2013; 13: 584-91. (Among 108 patients with chronic phase CML who had received at least two tyrosine kinase inhibitors and were treated with omacetaxine in two phase 2 trials, the overall hematologic response rate was 69% and side effects including myelosuppression, diarrhea, nausea, fatigue, infections and fever; no mention of ALT elevations and of liver related serious adverse events). 23787123
Kantarjian HM, O'Brien S, Cortes J. Homoharringtonine/omacetaxine mepesuccinate: the long and winding road to food and drug administration approval. Clin Lymphoma Myeloma Leuk 2013; 13: 530-3. (History of the development of omacetaxine as a therapy of CML; initially homoharringtonine, a natural plant alkaloid from Cephalotaxus trees, was studied extensively in China and reported to have activity against CML among other conditions; its cardiac toxicity and variability in purity led to semisynthetic modifications of the molecule [omacetaxine] and pharmacologically based dosing regimens and to its evaluation in cases of CML resistant to tyrosine kinase inhibitor therapy; future studies might focus on the combination of omacetaxine with tyrosine kinase inhibitors as first line therapy of CML). 23790799
Alvandi F, Kwitkowski VE, Ko CW, Rothmann MD, Ricci S, Saber H, Ghosh D, et al. U.S. Food and Drug Administration approval summary: omacetaxine mepesuccinate as treatment for chronic myeloid leukemia. Oncologist 2014; 19: 94-9. (Description of the results of phase 2 open label studies of omacetaxine on which the FDA based an accelerated approval, but requesting follow up studies to document the duration of responses and studies of the safety of home preparation and administration of the subcutaneous injections). 24309980
Khoury HJ, Cortes J, Baccarani M, Wetzler M, Masszi T, Digumarti R, Craig A, et al. Omacetaxine mepesuccinate in patients with advanced chronic myeloid leukemia with resistance or intolerance to tyrosine kinase inhibitors. Leuk Lymphoma 2015; 56: 120-7. (Among 95 patients with CML and resistance or intolerance of tyrosine kinase inhibitors who were treated with omacetaxine, 37% in the accelerated and 9% in blast phase had a hematologic response, and side effects were mostly due to myelosuppression; no mention of ALT elevations and no liver related serious adverse events). 24650054
Cortes JE, Kantarjian HM, Rea D, Wetzler M, Lipton JH, Akard L, Khoury HJ, et al. Final analysis of the efficacy and safety of omacetaxine mepesuccinate in patients with chronic- or accelerated-phase chronic myeloid leukemia: Results with 24 months of follow-up. Cancer 2015; 121: 1637-44. (Among 122 patients with CML resistant or intolerant to tyrosine kinase inhibitors who were treated with omacetaxine in phase 2 trials, final follow up showed overall survival of 40 months in chronic phase and 14 months in accelerated phase cases; hematologic adverse events occurred in 79% and 73% of patients and led to early discontinuation in 10% and 5%; 69 patients [56%] had at least one serious adverse event, but none were liver related). 25586015
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 5 [0.6%] were attributed to imatinib, but none to omacetaxine or other therapies of CML). 25754159
Omacetaxine (Synribo) for CML. Med Lett Drugs Ther 2015; 57 (1469): e80-1. (Concise review of the mechanism of action, clinical efficacy, safety and costs of omacetaxine shortly after the FDA gave final approval for its use in adults with CML with resistance to tyrosine kinase inhibitors; no mention of hepatotoxicity or ALT elevations). 26039555
Rosshandler Y, Shen AQ, Cortes J, Khoury HJ. Omacetaxine mepesuccinate for chronic myeloid leukemia. Expert Rev Hematol 2016; 9: 419-24. (Review of the development, mechanism of action, clinical efficacy and safety of omacetaxine; no mention of hepatotoxicity or ALT elevations). 26853281

## OTHER REFERENCE LINKS

1. Recent References on Omacetaxine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Omacetaxine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Omacetaxine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Omacetaxine)